# Ixazomib

## OVERVIEW

### Introduction

Ixazomib is a small molecule proteasome inhibitor that is used in combination with other antineoplastic agents to treat refractory multiple myeloma. Ixazomib is associated with a low rate of serum enzyme elevations during treatment and to rare instances of clinically apparent, acute liver injury.

### Background

Ixazomib (ix az' oh mib) is an orally available, small molecule inhibitor of the 26S proteasome, the intracellular complex that degrades proteins involved in cell signaling and cell cycle regulation. Blocking proteasome activity prevents activation of factors involved in cell growth and resistance to chemotherapy induced apoptosis, thereby leading to cancer cell death. Preclinical studies in vitro and in vivo suggested that ixazomib had activity against several hematologic malignancies. Clinical trials of the addition of ixazomib to lenalidomide and dexamethasone in patients with multiple myeloma showed improvements in progression free survival. Ixazomib given in combination with lenalidomide and dexamethasone received approval for use in the United States in 2015 for therapy of refractory multiple myeloma. Ixazomib is available in capsules of 2.3, 3 and 4 mg under the brand name Ninlaro. The recommended starting dose is 4 mg orally on days 1, 8 and 15 of 28-day cycles of lenalidomide and dexamethasone. A lower daily dose (3 mg) is recommended for patients with renal or hepatic impairment. Common side effects include nausea, diarrhea, constipation, anorexia, fatigue, peripheral edema, thrombocytopenia, neutropenia, anemia peripheral neuropathy, rash and fever. Uncommon, but potentially severe side effects include peripheral neuropathy, bone marrow suppression, thrombocytopenia, severe diarrhea and dehydration and embryo-fetal toxicity.

### Hepatotoxicity

In large clinical trials of ixazomib combined with lenalidomide and dexamethasone, elevations in serum aminotransferase levels were common, occurring in ~10% of patients. However, values greater than 5 times the upper limit of normal (ULN) were rare, occurring in <1% of recipients. Cases of clinically apparent liver injury including acute liver failure have been reported in patients receiving ixazomib, however in many instances multiple concomitant medications were being taken and the specific role of ixazomib in causing the liver injury was not always clear. The clinical features of cases of liver injury attributed to ixazomib have not been defined in any detail. Hepatotoxicity is listed as a warning in the product label for ixazomib and monitoring of serum enzymes during treatment is recommended.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury accounting for serum enzyme elevations and hepatic toxicity during ixazomib therapy is not known, but may be a direct effect of inhibition of hepatic proteasome activity. Ixazomib is metabolized in the liver largely through the CYP 3A4 pathway and liver injury may be related to production of a toxic intermediate. Ixazomib is susceptible to drug-drug interactions with agents that are strong inhibitors or inducers hepatic CYP 3A activity.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Clinically apparent liver injury should prompt immediate interruption of ixazomib therapy. Cases of hepatic failure attributed to ixazomib have been described, but no instance of chronic hepatitis or vanishing bile duct syndrome. The product label for ixazomib recommends monitoring of "hepatic enzymes" during treatment. There is little information on cross reactivity in risk for hepatic injury between ixazomib and other cancer chemotherapeutic agents including the tyrosine kinase inhibitors and other proteasome inhibitors such as carfilzomib and bortezomib but, because of the differences in chemical structure, there is little reason to suggest that there might be.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Related Drugs: Bortezomib, Carfilzomib, Lenalidomide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ixazomib – Ninlaro®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Ixazomib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ixazomib | 1072833-77-2 | C14-H19-B-Cl2-N2-O4 | Ixazomib structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 June 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of proteasome inhibitors such as ixazomib or bortezomib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 552. (Review of hepatotoxicity of cancer chemotherapeutic agents; bortezomib is listed as being implicated in causing hepatocellular injury, but ixazomib is not mentioned).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Laubach J, Hideshima T, Richardson P, Anderson K. Clinical translation in multiple myeloma: from bench to bedside. Semin Oncol 2013; 40: 549-53. (Review of recent development of new agents to treat multiple myeloma including bortezomib which showed activity against myeloma cell lines and was then evaluated clinically). 24135399
Kumar SK, Berdeja JG, Niesvizky R, Lonial S, Laubach JP, Hamadani M, Stewart AK, et al. Safety and tolerability of ixazomib, an oral proteasome inhibitor, in combination with lenalidomide and dexamethasone in patients with previously untreated multiple myeloma: an open-label phase 1/2 study. Lancet Oncol 2014; 15: 1503-12. (Among 65 patients with refractory multiple myeloma treated with ixazomib combined with lenalidomide and dexamethasone, dose limiting toxicities were nausea, diarrhea and skin rash). 25456369
Assouline SE, Chang J, Cheson BD, Rifkin R, Hamburg S, Reyes R, Hui AM, et al. Phase 1 dose-escalation study of IV ixazomib, an investigational proteasome inhibitor, in patients with relapsed/refractory lymphoma. Blood Cancer J 2014; 4: e251. (Among 30 patients with refractory lymphoma treated with different doses of ixazomib significant adverse events included neutropenia, thrombocytopenia, diarrhea, lymphopenia, rash and renal failure; no mention of ALT elevations or hepatotoxicity). 25325301
Kumar SK, Bensinger WI, Zimmerman TM, Reeder CB, Berenson JR, Berg D, Hui AM, et al. Phase 1 study of weekly dosing with the investigational oral proteasome inhibitor ixazomib in relapsed/refractory multiple myeloma. Blood 2014; 124: 1047-55. (Among 60 patients with refractory multiple myeloma treated with 4 different doses of ixazomib, dose limiting toxicities were nausea, diarrhea and skin rash; peripheral neuropathy developed in 40% of patients, and ALT elevations in 10%, which were above 5 times ULN in only 1 patient [2%]). 24904120
Wang H, Guan F, Chen D, Dou QP, Yang H. An analysis of the safety profile of proteasome inhibitors for treating various cancers. Expert Opin Drug Saf 2014: 1-12. (Review of efficacy and safety of bortezomib and several second-generation proteasome inhibitors including carfilzomib, marizomib, ixazomib and oprozomib; no discussion of hepatotoxicity or serum enzyme elevations). 25005844
Smith DC, Kalebic T, Infante JR, Siu LL, Sullivan D, Vlahovic G, Kauh JS, et al. Phase 1 study of ixazomib, an investigational proteasome inhibitor, in advanced non-hematologic malignancies. Invest New Drugs 2015; 33: 652-63. (Among 96 patients treated with intravenous ixazomib [twice weekly] toxicities included rash, thrombocytopenia, fatigue, dehydration and renal failure; no mention of ALT elevations or hepatotoxicity). 25777468
Moreau P, Masszi T, Grzasko N, Bahlis NJ, Hansson M, Pour L, Sandhu I, et al; TOURMALINE-MM1 Study Group. Oral ixazomib, lenalidomide, and dexamethasone for multiple myeloma. N Engl J Med 2016; 374: 1621-34. (Among 722 patients with refractory or relapsed multiple myeloma treated with lenalidomide and dexamethasone, progression free survival was improved by addition of ixazomib while serious adverse event rates were not [47% vs 49%]; side effects more common in ixazomib recipients included rash [36% vs 23%], vomiting [23% vs 12%], severe thrombocytopenia [12% vs 7%] and peripheral neuropathy [27% vs 22%], but not "liver impairment" [7% vs 6%]). 27119237
Three new drugs for multiple myeloma. Med Lett Drugs Ther 2016; 58 (1495): e70-1. (Concise summary of standard therapy for multiple myeloma and the mechanism of action, clinical efficacy, safety and costs of ixazomib, daratumumab and elotuzumab; does not mention liver related adverse events). 27192621
Schlafer D, Shah KS, Panjic EH, Lonial S. Safety of proteasome inhibitors for treatment of multiple myeloma. Expert Opin Drug Saf 2017; 16: 167-83. (Review of the safety of proteasome inhibitors including bortezomib, carfilzomib and ixazomib; mentions that rates of liver impairment are not increased by addition of ixazomib to lenalidomide and dexamethasone). 27841029

## OTHER REFERENCE LINKS

1. Recent References on Ixazomib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ixazomib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ixazomib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ixazomib)